# Cephalosporins, Parenteral

## OVERVIEW

### Introduction

The parenterally administered cephalosporins are widely used as broad spectrum antibiotics for moderate-to-severe infections with susceptible organisms. Despite their widescale use, cases of drug induced liver disease from the cephalosporins are rare, but more frequent with the parenteral forms.

### Background

Parenterally administered cephalosporins include cefazolin (Ancef: 1st generation), cefepime (Maxipime: 4th), cefiderocol (Fetroja: 4^th^), cefoperazone (Cefobid: 3rd), cefotaxime (Claforan: 3rd), cefoxitin (Mefoxin: 2nd), ceftaroline (Teflaro: 5th), ceftazidime (Ceptaz, Fortaz, Tazicef, Tazidime: 3rd), ceftibuten (3rd), ceftizoxime (Cefizox: 3rd), ceftolozane/tazobactam (Zerbaxa: 5th), ceftriaxone (Rocephin: 3rd), cefuroxime (Zinacef: 2nd), and cephradine (1st); the latter two are also available in oral formulations. Most of these cephalosporins can be given either intravenously or intramuscularly and are indicated for therapy of moderate-to-severe bacterial infections caused by susceptible organisms. Typical dose regimens in adults range from 250 mg, 500 mg, 1 gram or 2 grams every 6 to 12 hours for 7 to 14 days. The parenteral cephalosporins are widely used in medicine for serious infections and can be safely given to patients with advanced liver disease, dose modifications being required mainly for renal insufficiency. Many of these agents are also approved for use in children. The parenteral cephalosporins are generally well tolerated; adverse events can include diarrhea, nausea, abdominal pain, dyspepsia, headache, and rash. Rare but potentially severe adverse events include Clostridium difficile-associated diarrhea, hypersensitivity reactions, angioedema, anaphylaxis and Stevens Johnson syndrome/toxic epidermal necrolysis.

### Hepatotoxicity

Parenteral administration of cephalosporins can be associated with minor elevations in serum aminotransferase and alkaline phosphatase values, but these are generally mild, transient and not associated with symptoms or development of more severe liver injury. The frequency of these elevations is reported to be as high as 11%, but varies depending upon the frequency of monitoring, duration of therapy, and nature and severity of the underlying illness. Aminotransferase elevations above 5 times ULN are uncommon and typically occur in <1% of treated subjects.

Clinically apparent liver injury from parenteral cephalosporin administration is uncommon but multiple cases have been reported, although not all of the parenteral formulations have been linked to cases of liver injury. Cefazolin has been most frequently linked to cholestatic jaundice and ranks in the top 10 to 15 causes of jaundice from medications. It is also one of the most frequently used cephalosporins. The clinical pattern of injury suggests that hepatotoxicity is largely a class effect from the cephalosporins and is likely due to hypersensitivity. The typical latency period is 1 to 4 weeks with an abrupt onset of liver injury. Symptoms and jaundice can arise after the antibiotic has been stopped and typically consist of nausea, abdominal pain, pruritus and jaundice. The pattern of serum enzyme elevations is usually described as cholestatic, but mixed and hepatocellular instances have been reported. Liver injury is often accompanied by fever, rash and eosinophilia or other signs and symptoms of hypersensitivity. A history of penicillin allergy is not common, but the liver injury resembles that associated with penicillin hepatotoxicity. The course is usually self-limiting and the fatality rate is low as is typical of cholestatic hepatitis.

Likelihood score: A (cephalosporins as a class are well known and characterized, although uncommon, causes of clinically apparent liver injury, the association having been made largely with the most frequently used agents, such as cefazolin, cephalexin and ceftriaxone).

### Mechanism of Injury

The mechanism of hepatic injury due to cephalosporins is unknown, but believed to be hypersensitivity, similar to that of other penicillins. Cases of cholestatic liver injury attributed to cefazolin have been linked to HLA-A*02:01 which is a fairly common HLA allele, the allele frequency being 0.28 in the general population and 0.48 in patients with cefazolin induced liver injury.

### Outcome and Management

In most case reports, recovery has been rapid within 4 to 8 weeks, without residual injury or persistent serum enzyme elevations. Among the few cases reported, none have been fatal, although in some complicated cases the hepatic injury and cholestasis may have contributed to the mortality from the underlying illness. It is unclear whether there is cross sensitivity to hepatic injury or hypersensitivity reactions among the various cephalosporins. In many published cases, patients have been switched to an alternative cephalosporin without recurrence of injury, but it is more judicious to switch to another class of agents. Similarly, patients with a history of penicillin allergy have a higher rate of hypersensitivity reactions to cephalosporins, and they should be avoided or started with careful supervision and monitoring.

References to the safety and potential hepatotoxicity of parenteral cephalosporins are provided in the introductory overview chapter on Cephalosporins.

Drug Class: Antiinfective Agents, Cephalosporins

## CASE REPORT

### Case 1. Cholestatic hepatitis after single intravenous infusion of cefazolin.(1)

A 60 year old man received a single iv infusion of cefazolin during outpatient surgery and developed symptoms of liver disease 3 days later. He was healthy without major medical illnesses when he injured his shoulder while playing hockey. Approximately 2 months later, he underwent outpatient surgical repair of a torn right supraspinatus muscle under general anesthesia using inhaled nitrous oxide with intravenous propofol, fentanyl and midazolam. He also received a single intravenous infusion of 2 grams of cefazolin (a first generation parenteral cephalosporin) for prophylaxis against infection. Other perioperative medications included dimenhydrinate (Dramamine) and hydromorphone. The surgery lasted 5 hours and he recovered without incident, being sent home the same day with a prescription for a combination of acetaminophen (500 mg) and codeine (5 mg) 2 or 3 times daily for pain control, which he took as directed. Three days after surgery, he developed nausea and pruritus and 2 days later noted dark urine and jaundice. On testing, he had moderate elevations in serum aminotransferase and alkaline phosphatase levels and hyperbilirubinemia (Table). He was admitted for evaluation. His past medical history was remarkable for several previous orthopedic procedures. He had a history of asbestos exposure and mild chronic bronchitis for which he used albuterol by inhaler irregularly. He took occasional ibuprofen for muscle aches. He denied alcohol use or exposure to viral hepatitis. On admission to the hospital, he had mild eosinophilia (~640 cells/μl), but no rash or fever. Tests for hepatitis A, B and C were negative as well as autoantibodies. Ultrasound of the abdomen was normal. Importantly, review of two previous surgeries showed that he had received cefazolin at the time of both, and had jaundice following the second surgery that had been attributed to “halothane.” Careful review of anesthesia records showed no exposure to halogenated anesthetics during this third surgery; the names of the inhalational agent used during previous surgeries were not available.

#### Key Points

Medication: | Cefazolin, 2 g iv at time of surgery
Pattern: | Mixed → cholestatic (R=2.2→0.9)
Severity: | 3+ (jaundice and hospitalization)
Latency: | Three days
Recovery: | Complete 8 weeks
Other medications: | Chronically, salbutamol and ibuprofen, perioperatively nitrous oxide, fentanyl, propofol, midazolam, dramamine, acetaminophen with codeine

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | Pre | 24 | 65 | 0.4 | Presurgery evaluation
Orthopedic surgery under nitrous oxide and propofol, and iv cefazolin (2 g)
7 days | 6 days | 194 | 309 | 5.7 | 10% eosinophils
8 days | 7 days | 192 | 240 | 5.3
11 days | 10 days | 193 | 358 | 4.4
2 weeks | 13 days | 116 | 385 | 4.3
3 weeks | 20 days | 92 | 373 | 2.9
4 weeks | 27 days | 92 | 293 | 1.4
2 months | 2 months | 62 | 97 | 0.8 | No symptoms
8 months | 8 months | 20 | 60 | 0.6
Normal Values | | <40 | <140 | <1.2

#### Comment

Postoperative jaundice can be caused by sepsis, hypotension, viral hepatitis, benign postoperative cholestasis or anesthetic induced hepatotoxicity. Less well defined is postoperative liver disease due to other medications given at or around the time of surgery. In this instance, multiple medications were given in addition to inhaled nitrous oxide, but no halogenated anesthetics such as halothane, isoflurane, enflurane, desflurane or sevoflurane. In addition, the pattern of liver injury was typical of cephalosporins with short latency period, eosinophilia, cholestatic pattern of enzyme elevations and mild, self-limited course. Halothane hepatitis typically causes fever and is associated with a hepatocellular pattern of injury. Acetaminophen generally causes liver injury only when given in doses above 4 grams daily and causes marked aminotransferase elevations with minimal changes in alkaline phosphatase levels. Nitrous oxide and propofol have not been convincingly linked to drug induced liver injury. A single, intravenous administration of a cephalosporin at the time of outpatient surgery may be a more common cause of jaundice and liver injury than is currently thought.

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Cefazolin Sodium | 27164-46-1 | C14-H13-N8-Na-O4-S3 C14-H13-N8-O4-S3.Na C14-H14-N8-O4-S3.Na

## CITED REFERENCES

1 Alqahtani SA, Kleiner DE, Ghabril M, Gu J, Hoofnagle JH, Rockey DC; Drug-Induced Liver Injury Network (DILIN) Study Investigators. Identification and characterization of cefazolin-induced liver injury. Clin Gastroenterol Hepatol 2015; 13: 1328-36.e2.25528012

## NOTE

References to both the oral and parenteral cephalosporins as well as review articles on the relative frequency of cephalosporin-related liver injury are given in the overview chapter on Cephalosporins.